# Naltrexone-Bupropion

## OVERVIEW

### Introduction

The fixed combination of extended-release naltrexone and bupropion has been developed as a weight loss agent and was approved for use in the United States in 2014. This combination has not been linked to serum enzyme elevations or clinically apparent liver injury, but has had limited general use. Bupropion, approved for depression and as an aid for smoking cessation, has been implicated in rare instances of acute liver injury. Naltrexone, an opioid receptor antagonist, is used for opioid and alcohol dependency and has been shown to cause serum aminotransferase elevations when given in high doses but has not been shown to cause clinically apparent liver injury.

### Background

Naltrexone (nal trex’ one) has been available for many years as a therapy for opioid dependency, acting largely as an opiate receptor antagonist. Bupropion (bue proe’ pee on) was developed as an antidepressant and studies of its efficacy in patients with depression noted mild weight loss. Because both agents are fairly well tolerated, the combination was studied as an approach to weight loss. First in small pilot studies and later in sponsored, large randomized controlled trials, these studies showed that fixed combinations of these two agents led to weight loss that was significantly greater than occurred with placebo. The combination of naltrexone and bupropion was approved for use in the United States in 2014 as a weight loss agent for patients with obesity (BMI ≥30) or with BMI ≥27 plus an obesity-related comorbidity. There is only limited information on general clinical use of the combination. Fixed doses of naltrexone (8 mg) with bupropion (90 mg) are available as extended release tablets under the brand name of Contrave. The recommended initial dose is one tablet daily followed by a gradual in increase to two tablets twice daily (total daily dose 36 mg naltrexone and 360 mg of bupropion). Common side effects include paresthesias, dizziness, dry mouth, nausea, constipation, insomnia and change in taste. Uncommon side effects may include seizures (bupropion), vulnerability to opiate overdose and opioid withdrawal (naltrexone), increase in blood pressure, serum enzyme elevations (naltrexone), activation of mania (bupropion) and suicidal ideation and behaviors (bupropion) and hypersensitivity reactions. Bupropion is contraindicated in patients with anorexia nervosa or bulimia nervosa due to increased risk for seizures.

### Hepatotoxicity

In premarketing clinical trials, serum aminotransferase elevations were no more common among patients receiving the combination of naltrexone and bupropion than placebo. Clinically apparent liver injury due to this combination has not been reported, but several instances of acute liver injury have been linked to bupropion monotherapy of other conditions. In clinical trials of naltrexone alone, transient serum aminotransferase elevations occurred in approximately 25% of patients who received 300 mg daily, 6 times the recommended dose for opioid dependency. Some of the episodes of ALT elevations were associated with mild symptoms and slight bilirubin elevations, but all resolved rapidly upon stopping naltrexone. Case reports of liver injury attributed to naltrexone given in conventional doses have occurred largely in patients with alcohol or opioid dependency who have a high rate of underlying liver disease (viral hepatitis, alcoholic liver disease) and were characterized as serum aminotransferase elevations only. Thus, instances of clinically apparent liver injury have not been reported with the combination used as a weight loss product although both agents have been linked to liver injury when used alone.

Likelihood score: E* (suspected but unproven rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which naltrexone-bupropion might cause liver injury is not known. Because both agents have been associated with rare instances of liver injury, it is reasonable to assume that similar instances will occur with the combination if it is used as frequent as the individual agents. Bupropion is metabolized by CYP 2B6 and inhibits the activity of cytochrome CYP 2D6 which can result in significant drug-drug interactions.

### Outcome and Management

No instances of acute liver failure or chronic liver injury have been linked to naltrexone-bupropion, but it has had limited general clinical use. There is no reason to suspect that persons with hepatic injury attributed to this combination would exhibit cross sensitivity to liver injury from other weight loss agents.

References on the hepatotoxicity and safety of naltrexone and bupropion separately are given in the sections on the individual agents.

- Naltrexone
- Bupropion

Drug Class: Weight Loss Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Naltrexone-Bupropion – Contrave®

DRUG CLASS

Weight Loss Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=CONTRAVE+EXTENDED-RELEASE&pagesize=20&page=1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Naltrexone | 16590-41-3 | C20-H23-N-O4
Bupropion | 34911-55-2 | C13-H18-Cl-N-O

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999, well before the availability of naltrexone-bupropion).
FDA. Information on naltrexone-bupropion (Contrave). 2014. Available at: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2014/200063Orig1s000MedR.pdf (FDA website with Medical Review of naltrexone-bupropion for efficacy and safety used in its approval for as a weight loss agent, mentions that ALT elevations arose in 7 of 1515 placebo- [0.5%] vs 8 of 3239 drug-treated [0.6%] subjects which were greater than 3 times ULN in 0.2% vs 0.4%, and no patient developed clinically apparent liver injury with jaundice while cholecystitis was diagnosed in 1 patient on placebo [<0.1%] vs 6 on naltrexone-bupropion [0.3%]).
Malcolm R, O'Neil PM, Sexauer JD, Riddle FE, Currey HS, Counts C. (1985). A controlled trial of naltrexone in obese humans. Int J Obes. (Controlled trial of naltrexone [200 mg daily] or placebo for 8 weeks in 41 overweight subjects, found similar degrees of weight loss [-1.8 vs -1.5 kg] and adverse events [25% vs 55%], and 3 of 20 naltrexone treated subjects had ALT elevations above twice the ULN during treatment, resolving with stopping in 2 and attributed to alcohol use in one ).
Pfohl DN, Allen JI, Atkinson RL, Knopman DS, Malcolm RJ, Mitchell JE, Morley JE. (1986). Naltrexone hydrochloride (Trexan): a review of serum transaminase elevations at high dosage. NIDA Res Monogr. (Independent review of the ALT elevations occurring in controlled trials of naltrexone in obesity and dementia, found ALT and AST elevations occurring after 6-8 weeks in those receiving the highest dose [300 mg daily – 6 times recommended dose of substance abuse prevention] with peak levels of 10-15 times ULN rapidly improving with discontinuation only one with symptoms and one with mild bilirubin elevations].
Greenway FL, Dunayevich E, Tollefson G, Erickson J, Guttadauria M, Fujioka K, Cowley MA. (2009). NB-201 Study Group. Comparison of combined bupropion and naltrexone therapy for obesity with monotherapy and placebo. J Clin Endocrinol Metab. (Among 419 patients with uncomplicated obesity treated with naltrexone or bupropion or both [in 3 dose regimens] or placebo for 24 weeks, weight loss was greatest with the combination [-4.3% to -5.4%] compared to placebo [-0.8%], naltrexone alone [-1.2%] or bupropion alone [-2.7%], while common adverse events were nausea, headache, dizziness and insomnia and there were “no consistent clinically meaningful changes in laboratory values”).
Greenway FL, Fujioka K, Plodkowski RA, Mudaliar S, Guttadauria M, Erickson J, Kim DD, et al., COR-I Study Group. (2010). Effect of naltrexone plus bupropion on weight loss in overweight and obese adults (COR-I): a multicentre, randomised, double-blind, placebo-controlled, phase 3 trial. Lancet. (Among 1742 obese subjects treated with naltrexone-bupropion [16 or 32 mg/360 mg] or placebo for 56 weeks, weight loss was greatest with the combination [-5.0% and -6.1% vs -1.3%], while common adverse events were nausea, headache, constipation, dizziness and dry mouth and there were “no clinically significant effects…on…safety laboratory measures”).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none to naltrexone or bupropion).
Kang JG, Park CY. (2012). Anti-obesity drugs: a review about their effects and safety. Diabetes Metab J. (Review of the safety and efficacy of current and potentially future medications for obesity; mentions that several controlled trials have shown weight loss with naltrexone-bupropion and lists adverse side effects of nausea, headache, insomnia and constipation but does not mention ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (Population based prospective analysis of cases of drug induced liver injury seen over a two year period in Iceland identified 96 cases, none of which were attributed to naltrexone, bupropion or weight loss agents).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996-2012 identified 176 cases, none of which were attributed to naltrexone or bupropion, separately or together).
Wadden TA, Foreyt JP, Foster GD, Hill JO, Klein S, O'Neil PM, Perri MG, et al. (2011). Weight loss with naltrexone SR/bupropion SR combination therapy as an adjunct to behavior modification: the COR-BMOD trial. Obesity (Silver Spring). (Among 793 overweight or obese subjects treated with naltrexone-bupropion or placebo for 56 weeks, weight loss was greater with the drug combination [-9.3% vs -5.1%] and there were “no consistent effects … on clinical laboratory tests … and no evidence of treatment-related hepatotoxicity”).
Apovian CM, Aronne L, Rubino D, Still C, Wyatt H, Burns C, Kim D, Dunayevich E, COR-II Study Group. (2013). A randomized, phase 3 trial of naltrexone SR/bupropion SR on weight and obesity-related risk factors (COR-II). Obesity (Silver Spring). (Among 1496 obese or overweight subjects with dyslipidemia or hypertension treated with naltrexone-bupropion or placebo for 56 weeks, weight loss was greater with the drug combination [-6.1%vs -1.2%] and it had “no clinically significant effects … on laboratory measures”).
(2014). Contrave--a combination of bupropion and naltrexone for weight loss. Med Lett Drugs Ther. (Concise review of the mechanism of action clinical efficacy, safety and costs of naltrexone-bupropion [32 mg/360 mg per day] shortly after its approval as a weight loss agent in the US, mentions that aminotransferase elevations and hepatotoxicity have been reported with use of naltrexone alone).
Yanovski SZ, Yanovski JA. (2014). Long-term drug treatment for obesity: a systematic and clinical review. JAMA. (Systematic review of the literature on the efficacy of long term use of drugs for obesity that were FDA approved [at the time of the analysis] mentions that phentermine, diethylpropion and phendimetrazine are approved for short term use only, but that orlistat, lorcaserin and phentermine/topiramate are approved for long term use although their efficacy is modest; no discussion of hepatotoxicity).
Yanovski SZ, Yanovski JA. (2015). Naltrexone extended-release plus bupropion extended-release for treatment of obesity. JAMA. (Review of the mechanism of action, clinical efficacy and safety of naltrexone-bupropion, the 4^th^ agent approved in the US for long term therapy of obesity mentions that the mean weight loss across studies was -6.8% [-7.3 kg] at one year which was more than that reported in studies of orlistat and lorcaserin but less than with topiramate-phentermine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 were attributed to bupropion but none to naltrexone or to the combination).
Nissen SE, Wolski KE, Prcela L, Wadden T, Buse JB, Bakris G, Perez A, Smith SR. (2016). Effect of naltrexone-bupropion on major adverse cardiovascular events in overweight and obese patients with cardiovascular risk factors: a randomized clinical trial. JAMA. (Postmarketing study of naltrexone-bupropion therapy in 8910 overweight or obese subjects with cardiovascular risk factors found that major adverse cardiovascular events arose in 102 patients on placebo [2.3%] and in 90 on the drug combination [2.0%], while adverse events were more common with active therapy, gastrointestinal effects in 14% vs 2% and CNS symptoms in 5.1% vs 1.2% while weight change averaged -3.9 kg [-3.6%] vs -1.2 kg [-1.1%]; no mention of ALT elevations or hepatotoxicity).
Khera R, Murad MH, Chandar AK, Dulai PS, Wang Z, Prokop LJ, Loomba R, Camilleri M, Singh S. (2016). Association of pharmacological treatments for obesity with weight loss and adverse events: a systematic review and meta-analysis. JAMA. (Systematic review of 28 randomized controlled trials of weight loss drugs in 29,018 patients found significant weight loss in 23% of placebo recipients compared to 55% treated with naltrexone-bupropion, 75% with topiramate-phentermine, 63% with liraglutide, 49% with lorcaserin and 44% with orlistat, but with similar overall rates of adverse events; no mention of hepatotoxicity).
Mooney ME, Schmitz JM, Allen S, Grabowski J, Pentel P, Oliver A, Hatsukami DK. (2016). Bupropion and naltrexone for smoking cessation: A double-blind randomized placebo-controlled clinical trial. Clin Pharmacol Ther. (Among 121 treatment-seeking smokers treated with bupropion [300 mg] and placebo vs naltrexone and bupropion [50 mg/300 mg], abstinence was achieved in 54% on the combination compared to 33% on bupropion alone, while side effects were more frequent with the combination including nausea, lightheadedness, shakiness and stomach and muscle ache; no mention of ALT elevations or hepatotoxicity).
Saunders KH, Igel LI, Aronne LJ. (2016). An update on naltrexone/bupropion extended-release in the treatment of obesity. Expert Opin Pharmacother. (Review of the structure, mechanism of action, pharmacology, clinical efficacy and safety of naltrexone-bupropion mentions that studies identified “no clinically meaningful” changes in safety laboratory measures during therapy).
Aagaard L, Hallgreen CE, Hansen EH. (2016). Serious adverse events reported for antiobesity medicines: postmarketing experiences from the EU adverse event reporting system EudraVigilance. Int J Obes (Lond). (Analysis of adverse event reports from antiobesity medications to the European pharmacovigilance database [EudraVigilance] between 2007 and 2013 identified 4941 reports detailing 13,957 individual adverse events, 90% serious, only 15 attributed to phentermine with 2 deaths, but none were classified as hepatobiliary; naltrexone-bupropion was not included in the analysis).
Halpern B, Mancini MC. (2017). Safety assessment of combination therapies in the treatment of obesity: focus on naltrexone/ bupropion extended release and phentermine-topiramate extended release. Expert Opin Drug Saf. (Review of the mechanism of action, clinical efficacy and safety of fixed combination therapies for obesity discusses the common adverse events of naltrexone-bupropion including nausea [30% vs 9% with placebo], constipation [14% vs 6%], vomiting [10% vs 2.5%], dizziness [9% vs 3%] and headache [14% vs 9%], while serious adverse events were rare; no mention of ALT elevations or hepatotoxicity).
(2018). Diet, drugs, devices, and surgery for weight management. Med Lett Drugs Ther. (Concise review of the medical and surgical therapies for obesity mentions that for orlistat “severe liver injury has been reported rarely, but no cause-and-effect relationship has been established”; discussions of adverse events due to other weight loss agents [phentermine/ topiramate, naltrexone/bupropion, lorcaserin and liraglutide] do not mention ALT elevations or hepatotoxicity).
(2018). Comparison table: some FDA-approved drugs for weight management. Med Lett Drugs Ther. (Table comparing nine agents with FDA approval for use in weight management lists under the adverse events that “naltrexone can cause aminotransferase elevations and hepatotoxicity”).
Saunders KH, Umashanker D, Igel LI, Kumar RB, Aronne LJ. (2018). Obesity pharmacotherapy. Med Clin North Am. (Review of the pharmacotherapy of obesity focusing upon the 6 most commonly used medications, discusses the common side effects of naltrexone-bupropion, but does not discuss hepatotoxicity).
Patel DK, Stanford FC. (2018). Safety and tolerability of new-generation anti-obesity medications: a narrative review. Postgrad Med. (Review of the history of approval and indications, efficacy and long term safety of major currently available weight loss agents including orlistat, phentermine/topiramate, lorcaserin, liraglutide and naltrexone/bupropion; does not discuss hepatotoxicity).
Bello NT. (2019). Update on drug safety evaluation of naltrexone/bupropion for the treatment of obesity. Expert Opin Drug Saf. (Review of the efficacy and safety of naltrexone-bupropion mentions that naltrexone was approved in doses of 50 mg daily for opioid dependence in 1984 and alcohol dependence in 1994 and, when evaluated for obesity, had little effect despite high doses [up to 300 mg daily] which were associated with ALT elevations).
Onakpoya IJ, Lee JJ, Mahtani KR, Aronson JK, Heneghan CJ. Naltrexone-bupropion (Mysimba) in management of obesity: A systematic review and meta-analysis of unpublished clinical study reports. Br J Clin Pharmacol 2020; 86(4): 646-67. (Analysis of reports to US and European agencies on the efficacy and safety of naltrexone-bupropion found that therapy was associated with greater weight loss than was placebo, but a higher rate of adverse events; no mention of ALT elevations or hepatotoxicity).
Tak YJ, Lee SY. (2020). Anti-obesity drugs: long-term efficacy and safety: an updated review. World J Mens Health. (Review of currently available agents for long term therapy of obesity with specific discussion of mechanism of action, dosing regimen, efficacy and safety, mentions that naltrexone-bupropion therapy is associated with nausea, headache, dizziness, drug mouth, and gastrointestinal discomfort; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Naltrexone-Bupropion (Contrave): from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Contrave/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Naltrexone-Bupropion (Contrave): from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Contrave)